# Memantine

## OVERVIEW

### Introduction

Memantine is an oral N-methyl-D-aspartate glutamate receptor antagonist used in the therapy of Alzheimer disease and dementia. Memantine is associated with a minimal rate of serum enzyme elevations during therapy and has only rarely been implicated as a cause of clinically apparent acute liver injury.

### Background

Memantine (mem' an teen) is an antagonist of the N-methyl-D-aspartate (NMDA) glutamate receptors and has been shown to reduce the rate of clinical deterioration in moderate-to-severe Alzheimer disease. The mechanism by which inhibition of NMDA receptors is beneficial in dementia is not known, but Alzheimer disease is characterized by persistent activation of these receptors and their antagonism may reduce excitotoxicity. Memantine was approved for use in the United States in 2003 as therapy for moderate-to-severe dementia due to Alzheimer disease. Memantine is available in tablets of 5 and 10 mg and in capsules of extended release capsules of 7, 14, 21 and 28 mg generically and under the brand name Namenda. It is also available as an oral solution (2 mg/mL) and combination forms with donepezil. The usual maintenance dose is 10 to 20 mg daily of the standard formulation or 14 to 28 mg daily of the extended release capsules. Side effects are not common but can include headache, dizziness, agitation, anxiety, fatigue, insomnia, diarrhea, nausea, vomiting and rash.

### Hepatotoxicity

In large placebo controlled trials, the rate of serum enzyme elevations during memantine therapy was similar to that in patients on placebo and no instances of clinically apparent liver injury were reported. Nevertheless, since its introduction into clinical use, memantine has been implicated in at least one report of clinically apparent hepatotoxicity. The time to onset was 3 weeks and the clinical syndrome was that of an acute cholestatic hepatitis which was mild-to-moderate in severity and rapidly reversible upon drug discontinuation (Case 1). Immunoallergic and autoimmune features were not present.

Likelihood score: D (possible rare cause of clinically apparent liver injury).

### Mechanism of Injury

Memantine is minimally metabolized by the liver and excreted mainly in the urine. The mechanism by which it might cause hepatotoxicity is not known.

### Outcome and Management

Cases of hepatotoxicity from memantine have been too few to characterize clinically. There have been no published reports of acute liver failure, chronic hepatitis or vanishing bile duct syndrome attributed to memantine. There is no information on the possible cross sensitivity to liver injury of memantine with the acetylcholinesterase inhibitors or other NMDA antagonists such as amantadine.

References regarding the safety and potential hepatotoxicity of the drugs used for Alzheimer disease are provided together after the Overview section of Alzheimer Disease Agents.

Drug Class: Alzheimer Disease Agents

## CASE REPORT

### Case 1. Cholestatic hepatitis due to memantine.(1)

A 92 year old woman with dementia developed pruritus, dark urine and jaundice 16 days after starting memantine (5 mg daily for 8 days followed by 10 mg daily). She had no history of liver disease, risk factors for viral hepatitis or alcohol use. Her other medications included digoxin, lisinopril, tiapride, alprazolam and promazine which she had taken chronically. She had no history of drug allergies. She had no fever or rash. Liver tests showed serum bilirubin of 4.3 mg/dL (2.5 mg/dL direct), ALT 132 U/L, AST 74 U/L, alkaline phosphatase 912 U/L and GGT 155 U/L. Serum immunoglobulins were normal and AMA was negative as were tests for hepatitis A, B and C. Ultrasound of the abdomen showed no evidence of biliary obstruction. Memantine was discontinued and laboratory results began to improve (Table). Her other medications were continued. All liver tests were normal 20 days after stopping memantine.

#### Key Points

Medication: | Memantine (10 mg daily)
Pattern: | Cholestatic (R=0.3)
Severity: | 2+ (jaundice, no mention of hospitalization)
Latency: | 16 days
Recovery: | Within 20 days
Other medications: | Digoxin, lisinopril, tiapride, alprazolam and promazine

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
0 | | Memantine started (5 mg/d for 8 days, then 10 mg/d)
16 days | 1 day | 132 | 912 | 4.3 | Memantine stopped
20 days | 5 days | 71 | 1013 | 1.8 | Normal ultrasound
35 days | 20 days | 50 | 110 | 1.7
Normal Values | | <56 | <126 | <1.2

#### Comment

An elderly woman developed a mild cholestatic hepatitis within 2 to 3 weeks of starting memantine and recovered promptly with its discontinuation. The major differential diagnosis is biliary obstruction from gallstones or malignancy which was effectively excluded on the basis of the normal ultrasound, absence of fever and abdominal pain and full recovery on stopping the implicated medication. Memantine is generally well tolerated and liver injury from its use is very rare.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Memantine – Namenda®

DRUG CLASS

Alzheimer Disease Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Memantine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Memantine | 19982-08-2 | C12-H21-N

## CITED REFERENCE

1 Ferrara N, Corbi G, Capuano A, Filippelli A, Rossi F. (2008). Memantine-induced hepatitis with cholestasis in a very elderly patient. Ann Intern Med.

## ANNOTATED BIBLIOGRAPHY

References updated: 28 January 2020

Zimmerman HJ. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 709-42. (Expert review of hepatotoxicity published in 1999; tacrine, the first cholinesterase inhibitor approved for use in Alzheimer disease, was associated with a very high rate of serum ALT elevations [~50%], but rarely caused clinically apparent liver injury; the other Alzheimer disease agents are not discussed).
Larrey D, Ripault MP. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 518. (Review of hepatotoxicity of psychotropic agents ; drugs for Alzheimer disease are not specifically discussed).
Roberson ED. Alzheimer's disease. Treatment of central nervous system degenerative disorders. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 333-5. (Textbook of pharmacology and therapeutics).
Reisberg B, Doody R, Stöer A, Schmitt F, Ferris S, Mös HJ, Memantine Study Group. (2003). Memantine in moderate-to-severe Alzheimer's disease. N Engl J Med. (Controlled trial of 28 weeks of memantine vs placebo in 252 patients with Alzheimer disease; no differences in rates of any adverse event; serum ALT levels and hepatotoxicity not mentioned).
Tariot PN, Farlow MR, Grossberg GT, Graham SM, McDonald S, Gergel I, Memantine Study Group. (2004). Memantine treatment in patients with moderate to severe Alzheimer disease already receiving donepezil: a randomized controlled trial. JAMA. (Controlled trial of 24 weeks of memantine vs placebo in 404 patients with Alzheimer disease receiving donepezil: side effects that were more common with memantine were confusion and headache; "No clinically significant differences were detected between treatment groups...in laboratory tests").
Bullock R. (2006). Efficacy and safety of memantine in moderate-to-severe Alzheimer disease: the evidence to date. Alzheimer Dis Assoc Disord. (Review of the safety of memantine from 3 pivotal controlled trials and more than 100,000 patient-years of use: overall rates of side effects were not different from placebo, were mild-to-moderate, and often considered unrelated; no mention of hepatotoxicity).
Farlow MR, Cummings JL. (2007). Effective pharmacologic management of Alzheimer's disease. Am J Med. (Review of safety and efficacy of medications for Alzheimer disease; no discussion of hepatotoxicity).
Bakchine S, Loft H. (2008). Memantine treatment in patients with mild to moderate Alzheimer's disease: results of a randomised, double-blind, placebo-controlled 6-month study. J Alzheimers Dis. (Controlled trial of 24 weeks of memantine vs placebo in 470 patients with Alzheimer disease: adverse events occurred in similar rates with memantine and placebo, were all mild-to-moderate, and there "were no clinically meaningful differences between treatment groups" in laboratory tests).
Ferrara N, Corbi G, Capuano A, Filippelli A, Rossi F. (2008). Memantine-induced hepatitis with cholestasis in a very elderly patient. Ann Intern Med. (92 year old woman developed jaundice and pruritus 16 days after starting memantine for dementia [bilirubin 4.3 mg/dL, ALT 132 U/L, Alk P 912 U/L], resolving within 3 weeks of stopping).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008; none were attributed to a drug used to treat Alzheimer disease).
Mayeux R. (2010). Early Alzheimer's disease. N Engl J Med. (Case discussion and review of current understanding of Alzheimer disease including role of therapy; common side effects of cholinesterase inhibitors include nausea, vomiting, anorexia, diarrhea, dizziness, muscle cramps, insomnia and vivid dreams; memantine can cause constipation, dizziness, headache and body pains; no mention of hepatotoxicity).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were attributed to drugs used to treat Alzheimer disease).
Tan CC, Yu JT, Wang HF, Tan MS, Meng XF, Wang C, Jiang T, et al. (2014). Efficacy and Safety of donepezil, galantamine, rivastigmine, and memantine for the treatment of Alzheimer's disease: a systematic review and meta-analysis. J Alzheimers Dis. (Systematic review of safety and efficacy of 4 Alzheimer drugs does not mention ALT elevations or hepatotoxicity).
Tricco AC, Soobiah C, Berliner S, Ho JM, Ng CH, Ashoor HM, Chen MH, Hemmelgarn B, Straus SE. (2013). Efficacy and safety of cognitive enhancers for patients with mild cognitive impairment: a systematic review and meta-analysis. CMAJ. (Systematic review of 8 clinical trials and 3 reports on the safety and efficacy of Alzheimer drugs mentions that side effects of nausea, diarrhea, vomiting and headaches were usually more frequent with the active drugs compared to placebo; no mention of ALT elevations or clinically apparent liver injury).
Wang HF, Yu JT, Tang SW, Jiang T, Tan CC, Meng XF, Wang C, et al. (2015). Efficacy and safety of cholinesterase inhibitors and memantine in cognitive impairment in Parkinson's disease, Parkinson's disease dementia, and dementia with Lewy bodies: systematic review with meta-analysis and trial sequential analysis. J Neurol Neurosurg Psychiatry. (Systematic review of 10 trials of Alzheimer disease drugs in Parkinson disease and other forms of dementia reported that the common adverse events were cholinergic in nature [anorexia, nausea, diarrhea] and were generally mild-to-moderate in severity; serious adverse events were similar to rates with placebo; no mention of ALT elevations or hepatotoxicity).
Nakamura Y, Kitamura S, Homma A, Shiosakai K, Matsui D. (2014). Efficacy and safety of memantine in patients with moderate-to-severe Alzheimer's disease: results of a pooled analysis of two randomized, double-blind, placebo-controlled trials in Japan. Expert Opin Pharmacother. (Among 633 Japanese patients with Alzheimer disease treated with either memantine or placebo, the rate of adverse events was similar in the two groups; no mention of ALT elevations or clinically apparent liver injury).
Dysken MW, Sano M, Asthana S, Vertrees JE, Pallaki M, Llorente M, Love S, et al. (2014). Effect of vitamin E and memantine on functional decline in Alzheimer disease: the TEAM-AD VA cooperative randomized trial. JAMA. (Among 561 patients with Alzheimer disease treated with vitamin E, memantine, the combination or placebo for an average of 2.3 years, overall adverse events were similar in the 4 groups, but serious infections were more common with memantine than placebo (15% vs 7%); no mention of ALT elevations or hepatotoxicity).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none of the cases were attributed to a drug used to treat Alzheimer disease).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, none were attributed to a drug for Alzheimer disease).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were due to a drug for Alzheimer disease).
Dou KX, Tan MS, Tan CC, Cao XP, Hou XH, Guo QH, Tan L, et al. (2018). Comparative safety and effectiveness of cholinesterase inhibitors and memantine for Alzheimer's disease: a network meta-analysis of 41 randomized controlled trials. Alzheimers Res Ther. (Meta-analysis of 41 published randomized controlled trials of drugs for Alzheimer disease concluded that all had beneficial effects on cognition and function but not on neuropsychiatric symptoms, and all had adverse effects but memantine showed “the best profile of acceptability”; no mention of ALT elevations or hepatotoxicity).
Khoury R, Rajamanickam J, Grossberg GT. (2018). An update on the safety of current therapies for Alzheimer's disease: focus on rivastigmine. Ther Adv Drug Saf. (Review of the safety of Alzheimer disease agents discusses gastrointestinal adverse events, cardiac side effects, skin reactions [to transdermal formulations] and neuropsychiatric effects, but not hepatic adverse events).
Matsunaga S, Kishi T, Nomura I, Sakuma K, Okuya M, Ikuta T, Iwata N. (2018). The efficacy and safety of memantine for the treatment of Alzheimer's disease. Expert Opin Drug Saf. (Review of the literature on efficacy and safety of memantine concluded that it improves cognitive function and behavioral disturbances and is well tolerated, most common adverse events being somnolence and weight gain; does not discuss ALT elevations or hepatotoxicity, but mentions that hepatitis is listed as an adverse event in the product label).
Bhattacharjee S, Patanwala AE, Lo-Ciganic WH, Malone DC, Lee JK, Knapp SM, Warholak T, Burke WJ. (2019). Alzheimer's disease medication and risk of all-cause mortality and all-cause hospitalization: A retrospective cohort study. Alzheimers Dement (N Y). (Among more than 20,000 Medicare beneficiaries receiving Alzheimer disease drugs, overall survival was better for those on donepezil than memantine or rivastigmine; no mention of serious hepatic adverse events or liver related deaths).
Shumar J, Ordway S, Junga Z, Sadowski B, Torres D. (2019). Memantine-induced liver injury with probable causality as assessed using the Roussel Uclaf Causality Assessment Method (RUCAM). ACG Case Rep J. (An 86 year old man with Alzheimer disease was found to have abnormal liver tests without symptoms or jaundice, 2 months after adding memantine to his usual medications [ALT 439 U/L, Alk P 169 U/L, bilirubin 0.9 mg/dL], resolving within 6 months of stopping memantine only).
Li DD, Zhang YH, Zhang W, Zhao P. (2019). Meta-analysis of randomized controlled trials on the efficacy and safety of donepezil, galantamine, rivastigmine, and memantine for the treatment of Alzheimer's disease. Front Neurosci. (Meta-analysis of 36 controlled trials of drugs for Alzheimer disease focusing upon relative efficacy and rates of discontinuation in comparison to placebo).

## OTHER REFERENCE LINKS

1 Recent References on Memantine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Memantine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Memantine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Memantine)